# Safinamide

## OVERVIEW

### Introduction

Safinamide is an inhibitor of monoamine oxidase used as adjunctive therapy in combination with levodopa and carbidopa in the management of Parkinson’s disease. Safinamide has been associated with a low rate of serum enzyme elevations during treatment, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Safinamide (sa fin' a mide) is a potent and highly specific inhibitor of monoamine oxidase (MAO) type B which is a major enzyme in the degradation pathway of dopamine and levodopa metabolism. As a result, safinamide results in an increase in the bioavailability of levodopa enhancing and increasing the duration of its effects in Parkinson disease. Safinamide was approved for use in the United States in 2017, the third MAO-B inhibitor approved for use in Parkinson disease, and is currently approved for use only as an adjunct to levodopa therapy. Safinamide is available in tablets of 50 and 100 mg under the brand name Xadago. Safinamide is typically given in oral doses of 50 or 100 mg once daily in combination with levodopa/carbidopa. Common side effects include dyskinesia, falls, nausea, abdominal pain, cough, hypertension, headache, blurred vision, dizziness, insomnia and tremor–most of which are attributable to enhanced dopaminergic effects. Rare, but potentially severe side effects include severe hypertension, serotonin syndrome, daytime sleepiness, hallucinations, difficulties with impulse control, hypersexuality and compulsive behavior. Unlike some other MAO inhibitors, safinamide has not been shown to cause increased susceptibility to dietary tyramine inducing hypertensive crises ("cheese effect").

### Hepatotoxicity

Safinamide has been reported to cause serum enzyme elevations in a small proportion of patients treated long term, although the abnormalities were usually mild and self-limiting and were usually no more frequent than with placebo or comparator agents. Safinamide has not been implicated in cases of acute liver injury, but such instances have been reported with nonspecific MAO inhibitors.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which safinamide might cause liver injury is not known. Safinamide is extensively metabolized but has no effect on cytochrome P450 enzymes or hepatic transporters and significant drug-drug interactions have not been demonstrated. Patients taking MAO inhibitors should avoid use of serotonin reuptake inhibitors and sympathomimetic medications.

### Outcome and Management

Instances of hepatotoxicity attributed to safinamide have been mild and self-limiting elevations in serum enzymes. No instances of severe liver injury, acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been linked to safinamide use.

Drug Class: Antiparkinson Agents

Other Drugs in the Subclass, Selective MAO-B Inhibitors: Rasagiline, Selegiline

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Safinamide – Generic, Xadago®

DRUG CLASS

Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Safinamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Safinamide | 133865-89-1 | C17-H19-F-N2-O2 | Safinamide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2019

Zimmermam HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine, but not selegiline, rasagiline or safinamide).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Roberson ED. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 327-38. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that “shifts from baseline to high levels” of ALT and AST were more frequent with safinamide than placebo treatments in several clinical trials but no actual values, timing or duration of elevations were provided).
Lambert D, Waters CH. Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging 2000; 16: 55-65. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease). 10733264
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to agents used for Parkinson disease). 20949552
Stocchi F, Borgohain R, Onofrj M, Schapira AH, Bhatt M, Lucini V, Giuliani R, Anand R; Study 015 Investigators. A randomized, double-blind, placebo-controlled trial of safinamide as add-on therapy in early Parkinson's disease patients. Mov Disord 2012; 27: 106-12. (Among 269 patients with early Parkinson disease on a dopamine agonist to which was added safinamide [100 or 200 mg daily] or placebo for 24 weeks, responses were more frequent with the 100 mg dose than with placebo or the 200 mg dose, while adverse event rates were similar in all three groups and “the incidence of clinically notable values for laboratory parameters and vital signs were comparable between groups”). 21913224
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease). 23419359
Drugs for Parkinson's disease. Treat Guidel Med Lett 2017; 59 (1534): 198-94. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy, adverse events and costs; does not mention ALT elevations or hepatotoxicity, “whether safinamide is more effective or has a more favorable safety profile than the other irreversible MAO-B inhibitors is unknown”). 29136401
Schapira AH, Stocchi F, Borgohain R, Onofrj M, Bhatt M, Lorenzana P, Lucini V, et al.; Study 017 Investigators. Long-term efficacy and safety of safinamide as add-on therapy in early Parkinson's disease. Eur J Neurol 2013; 20: 271-80. (Among 227 patients who enrolled in an extension study after participation in a randomized controlled trial [Stocchi 2012] and were treated with either safinamide [100 or 200 mg] or placebo, changes in symptoms and response rates were similar in the 3 groups as well total and serious adverse event rates; no mention of ALT elevations or hepatotoxicity). 22967035
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease). 24552865
Borgohain R, Szasz J, Stanzione P, Meshram C, Bhatt MH, Chirilineau D, Stocchi F, et al.; Study 018 Investigators. Two-year, randomized, controlled study of safinamide as add-on to levodopa in mid to late Parkinson's disease. Mov Disord 2014; 29: 1273-80. (Among 669 patients with Parkinson disease on long term levodopa therapy who were treated with safinamide [50 or 100 mg] or placebo, troublesome dyskinesia was less with safinamide and adverse event rates were similar in all 3 groups and “there were no significant findings for clinical laboratory tests”). 25044402
Borgohain R, Szasz J, Stanzione P, Meshram C, Bhatt M, Chirilineau D, Stocchi F, et al.; Study 016 Investigators. Randomized trial of safinamide add-on to levodopa in Parkinson's disease with motor fluctuations. Mov Disord 2014; 29: 229-37. (Among 669 patients with mid- to late-stage Parkinson disease treated with safinamide [50 or 100 mg daily] or placebo as add-on therapy to levodopa and other therapies for 24 weeks and then continued on same regimen for another 12 months, improvement in total dyskinesia score was similar in all 3 groups as were most adverse event rates; no mention of ALT elevations or hepatotoxicity). 24323641
Deeks ED. Safinamide: first global approval. Drugs 2015; 75: 705-11. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of safinamide; mentions common adverse events of dyskinesia, insomnia, somnolence, dizziness, headache, cataract, orthostatic hypotension, nausea and falls but not ALT elevations or hepatotoxicity). 25851099
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease). 25754159
Safinamide(Xadago) for Parkinson's disease. Med Lett Drugs Ther 2017; 59 (1529): 151-3. (Concise review of the standard therapy of Parkinson disease, the mechanism of action of safinamide, its clinical efficacy, safety and costs shortly after its approval for use in the US; mentions that it can cause mild ALT and AST elevations but does not mention clinically apparent liver injury). 28880847
Jiménez-Jiménez FJ, Alonso-Navarro H, Valle-Arcos D. Hypersexuality possibly associated with safinamide. J Clin Psychopharmacol 2017; 37: 635-6. (75 year old woman with Parkinson disease on multiple agents for several years developed increased libido and obsessive sexual urges 5 months after switching from rasagiline to safinamide [100 mg daily] combined with levodopa/carbidopa, symptoms becoming increasingly distressful and then resolving completely and permanently one week after stopping safinamide). 28796020
Schapira AH, Fox SH, Hauser RA, Jankovic J, Jost WH, Kenney C, Kulisevsky J, et al. Assessment of safety and efficacy of safinamide as a levodopa adjunct in patients with Parkinson disease and motor fluctuations: a randomized clinical trial. JAMA Neurol 2017; 74: 216-24. (Among 549 patients with Parkinson disease who were treated with safinamide [50 mg raised to 100 mg after 2 weeks] or placebo added to levodopa [with or without other agents] for 24 weeks, there was an increase in time with control of motor fluctuations without troublesome dyskinesia with safinamide therapy while overall and severe adverse event rates were similar and there were “no clinically meaningful mean changes in…laboratory values”). 27942720
Mancini F, Di Fonzo A, Lazzeri G, Borellini L, Silani V, Lacerenza M, Comi C. Real life evaluation of safinamide effectiveness in Parkinson's disease. Neurol Sci 2018; 39: 733-9. (Among 91 patients with Parkinson disease treated with safinamide for motor fluctuations and dyskinesias, most patients experienced improvement while 8 discontinuation therapy because of side effects, but none because of ALT elevations or hepatotoxicity). 29441484

## OTHER REFERENCE LINKS

1. Recent References on Safinamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Safinamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Safinamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Safinamide)